# Iloperidone

## OVERVIEW

### Introduction

Iloperidone is a second generation (atypical) antipsychotic agent that is used for treatment of schizophrenia. Iloperidone is associated with a low rate of serum aminotransferase elevations during therapy and has not been linked to instances of clinically apparent acute liver injury.

### Background

Iloperidone (eye" loe per' i done) is a second-generation antipsychotic agent which appears to act as a dopamine type 2 (D2) and serotonin (5-HT)-2A receptor antagonist whose structure and mechanism of action are similar to risperidone. Several randomized controlled trials have shown that iloperidone improves symptoms of schizophrenia with effects comparable to risperidone and ziprasidone. Iloperidone was approved for use in adults with schizophrenia in the United States in 2009 and is available as tablets of 1, 2, 4, 6, 8, 10 and 12 mg generically and under the brand name Fanapt. The recommended dose regimen is a slow escalation to a maintenance dose in adults is 6 to 12 mg twice daily. Common side effects of include dizziness, dry mouth, somnolence, fatigue, nasal congestion, anxiety, restlessness (akathisia), peripheral edema, sexual dysfunction, weight gain and changes in glucose and lipid levels. Iloperidone therapy is also associated with postural hypotension and prolongation of the QTc interval. Rare, but potentially severe adverse reactions (mentioned in most antipsychotic and antidepressant product labels) include increased mortality in elderly patients with dementia-related psychosis and suicidal thoughts and behaviors. Other rate adverse reactions are tardive dyskinesia, major neurologic events, neuroleptic malignant syndrome, priapism, orthostatic hypotension, seizures, suicidal thoughts and behaviors, and neutropenia.

### Hepatotoxicity

Liver test abnormalities occur in 1% to 3% of patients on long term therapy with iloperidone, but similar rates are reported with placebo therapy and with comparator agents. The ALT elevations are usually mild, transient and usually resolve even without dose modification or drug discontinuation. There have been no published reports of clinically apparent liver injury with symptoms or jaundice attributed to iloperidone therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which iloperidone might cause serum ALT elevations or liver injury is not known. Iloperidone is extensively metabolized by the cytochrome P450 system (CYP 2D6 and 3A4) to its active metabolite and is susceptible to drug-drug interactions with agents that inhibit or induce these microsomal enzymes.

### Outcome and Management

The serum aminotransferase elevations that occur on iloperidone therapy are usually self-limited and usually do not require dose modification or discontinuation. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been attributed to iloperidone. Cross sensitivity to liver related or other hypersensitivity reactions between iloperidone and structurally related antipsychotic agents (such as lurasidone, paliperidone, risperidone and ziprasidone) have not been demonstrated, but may well occur.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Iloperidone – Generic, Fanapt®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Iloperidone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Iloperidone | 133454-47-4 | C24-H27-F-N2-O4
Risperidone | 106266-06-2 | C23-H27-F-N4-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Larry D. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 507-26. (Review of hepatotoxicity of psychiatric agents does not discuss iloperidone).
Kane JM, Lauriello J, Laska E, Di Marino M, Wolfgang CD. (2008). Long-term efficacy and safety of iloperidone: results from 3 clinical trials for the treatment of schizophrenia. J Clin Psychopharmacol. (Among 371 adults with schizophrenia who were continued on iloperidone for 46 weeks after their participation in a controlled trial, adverse events included insomnia [18%] and anxiety [11%], but “there were no significant effects on liver function tests”).
Cutler AJ, Kalali AH, Weiden PJ, Hamilton J, Wolfgang CD. (2008). Four-week, double-blind, placebo- and ziprasidone-controlled trial of iloperidone in patients with acute exacerbations of schizophrenia. J Clin Psychopharmacol. (Among 593 patients with schizophrenia treated with iloperidone [24 mg daily], ziprasidone [160 mg daily] or placebo for 4 weeks, symptom scores improved in both the active treatment groups and side effects from iloperidone included dizziness, sedation, weight gain, dry mouth, tachycardia and nasal congestion; “mean changes in laboratory values from baseline to end point were similar across treatment groups”).
Weiden PJ, Cutler AJ, Polymeropoulos MH, Wolfgang CD. (2008). Safety profile of iloperidone: a pooled analysis of 6-week acute-phase pivotal trials. J Clin Psychopharmacol. (Among 1943 adults with schizophrenia treated with various doses of iloperidone, haloperidol, risperidone or placebo for 6 weeks, side effects of iloperidone included dizziness, dry mouth, fatigue, nasal congestion, somnolence and tremor; 1 of 1044 patients on iloperidone, but none of 440 on placebo had a serious adverse event related to serum enzyme elevations; no specific details given).
Potkin SG, Litman RE, Torres R, Wolfgang CD. (2008). Efficacy of iloperidone in the treatment of schizophrenia: initial phase 3 studies. J Clin Psychopharmacol. (Among 1943 adults with schizophrenia enrolled in 3 controlled trials of various doses of iloperidone versus haloperidol, risperidone or placebo for 6 weeks, symptom scores improved more with iloperidone than placebo and to a similar extent as with the comparator arms; side effects were not discussed [Weiden 2008]).
Parsons B, Allison DB, Loebel A, Williams K, Giller E, Romano S, Siu C. (2009). Weight effects associated with antipsychotics: a comprehensive database analysis. Schizophr Res. (Analysis of weight gain in 21 placebo-controlled trials of antipsychotic agents [~3300 patients]; average monthly weight gain in pounds was +0.1 with placebo, +0.8 olanzapine, 0.6 risperidone, -0.3 ziprasidone; a 5% increase in weight occurred after one year in 13% of placebo, 39% haloperidol, 20% ziprasidone, 45% risperidone and 60% olanzapine treated subjects).
(2010). Iloperidone (Fanapt)--another second-generation antipsychotic. Med Lett Drugs Ther. (Brief review of efficacy and safety of iloperidone shortly after its approval in the US; common side effects are restlessness, nausea, extrapyramidal symptoms, agitation, and somnolence; no mention of liver injury).
Citrome L. (2010). Iloperidone: chemistry, pharmacodynamics, pharmacokinetics and metabolism, clinical efficacy, safety and tolerability, regulatory affairs, and an opinion. Expert Opin Drug Metab Toxicol. (Review of the chemistry, pharmacology, efficacy, and safety of iloperidone mentions that it can prolong the QTc interval but has not been linked to instances of sudden death; side effects can include weight gain, dizziness, sedation and postural hypotension, but restlessness [akathisia] and extrapyramidal side effects are rare; no mention of ALT elevations or hepatotoxicity).
Dargani NV, Malhotra AK. (2014). Safety profile of iloperidone in the treatment of schizophrenia. Expert Opin Drug Saf. (Systematic review of safety of iloperidone in schizophrenia found 12% rate of significant weight gain, but low rates of akathisia and extrapyramidal symptoms: no mention of ALT elevations or hepatotoxicity).
Muzyk AJ, Cvelich RG, Kincaid BR, Preud'homme XA. (2012). Angioedema occurring in patient prescribed iloperidone and haloperidol: a cross-sensitivity reaction to antipsychotics from different chemical classes. J Neuropsychiatry Clin Neurosci. (24 year old African-American man developed hypersensitivity reaction [angioedema] within 24 hours of starting haloperidol and, after recovery, developed a similar reaction 3 days after starting iloperidone, both episodes responding rapidly to antihistamines and corticosteroids).
Cutler AJ, Kalali AH, Mattingly GW, Kunovac J, Meng X. (2013). Long-term safety and tolerability of iloperidone: results from a 25-week, open-label extension trial. CNS Spectr. (Among 72 patients with schizophrenia who were continued on iloperidone for 25 weeks after participation in a 4-week controlled trial, side effects included headache, weight gain, dizziness, nausea, sedation and insomnia; no mention of ALT elevations or hepatotoxicity).
(2013). Drugs for psychiatric disorders. Treat Guidel Med Lett. (Concise review of safety, efficacy and role of drugs for psychiatric disorders, mentions that iloperidone is a second-generation antipsychotic agent whose adverse side effects include orthostatic hypotension, prolongation of the QTc interval, somnolence, dizziness, dry mouth and weight gain, but rarely has extrapyramidal effects; no mention of ALT elevations or hepatotoxicity).
Rado JT, Janicak PG. (2014). Long-term efficacy and safety of iloperidone: an update. Neuropsychiatr Dis Treat. (Review of the efficacy and safety of iloperidone makes no mention of ALT elevations or hepatotoxicity).
Musil R, Obermeier M, Russ P, Hamerle M. (2015). Weight gain and antipsychotics: a drug safety review. Expert Opin Drug Saf. (Extensive systematic review of the literature on the problem of weight gain during therapy with antipsychotic agents, mentions that weight gain of 7% or more occurs in 9-47% of patients on iloperidone, the rates being lower than with olanzapine, but higher than with aripiprazole).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology. (Among 899 cases of drug induced liver injury seen over a ten year period at 8 US medical centers, one was attributed olanzapine, but none to iloperidone or other antipsychotic medications).
Weiden PJ, Manning R, Wolfgang CD, Ryan JM, Mancione L, Han G, Ahmed S, et al. (2016). A randomized trial of iloperidone for prevention of relapse in schizophrenia: the REPRIEVE Study. CNS Drugs. (Among 303 patients with schizophrenia who were placed on iloperidone and stabilized, those continued on iloperidone were less likely to relapse than those switched to placebo [20% vs 64%], while adverse event rates were similar; no mention of ALT elevations or hepatotoxicity).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome, but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone and lurasidone).
Solmi M, Murru A, Pacchiarotti I, Undurraga J, Veronese N, Fornaro M, Stubbs B, et al. (2017). Safety, tolerability, and risks associated with first- and second-generation antipsychotics: a state-of-the-art clinical review. Ther Clin Risk Manag. (Extensive review of the safety of antipsychotic medications mentions that significant liver enzyme elevations are rare, but have been reported with olanzapine, quetiapine, and risperidone and that clinically apparent acute liver injury has been reported with phenothiazines, halothane and clozapine; no mention of hepatotoxicity associated with iloperidone).
Subeesh V, Maheswari E, Singh H, Beulah TE, Swaroop AM. (2019). Novel adverse events of iloperidone: A disproportionality analysis in US Food and Drug Administration Adverse Event Reporting System (FAERS) database. Curr Drug Saf. (Data mining of the FDA’s Adverse Event Reporting System for adverse events associated with iloperidone, identified signals for akathisia, dyskinesia, peripheral edema, priapism and sexual disfunction, but not for ALT elevations or clinically apparent liver injury).
Nair A, Salem A, Asamoah AL, Gosal R, Grossberg GT. (2020). An update on the efficacy and safety of iloperidone as a schizophrenia therapy. Expert Opin Pharmacother. (Comprehensive review of the chemical structure, mechanism of action, clinical efficacy, adverse events, and relative efficacy and safety of iloperidone in comparison to other second-generation antipsychotic agents, mentions that it has a low likelihood of causing liver injury).
Druschky K, Toto S, Bleich S, Baumgärtner J, Engel RR, Grohmann R, Maier HB, et al. (2021). Severe drug-induced liver injury in patients under treatment with antipsychotic drugs: data from the AMSP study. World J Biol Psychiatry. (Among 246 cases of severe liver injury due to antipsychotic medications identified in a prospective registry of German psychiatric hospitals between 1993 and 2016, 46 arose in 38,349 patients [0.12%] who received clozapine [34 as a single antipsychotic agent]; other commonly implicated agents being olanzapine [n=90 of 54,822: 0.16%], quetiapine [34 of 66,209: 0.05%] and risperidone [27 of 51,683: 0.05%]; two fatal cases occurred in olanzapine-treated patients; low rates were found for ziprasidone [no cases among 3568 patients treated] and aripiprazole [6 cases of 15,988 patients treated: 0.01%]; iloperidone not listed).

## OTHER REFERENCE LINKS

1 Recent References on Iloperidone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Iloperidone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Iloperidone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Iloperidone)